# Ponesimod

## OVERVIEW

### Introduction

Ponesimod is an orally available sphingosine-1-phosphate (S1P) receptor modulator that acts as an immunomodulatory drug and is used to treat relapsing forms of multiple sclerosis. Ponesimod is associated with transient serum enzyme elevations during therapy but has not been linked to instances of clinically apparent liver injury with jaundice, although experience with its use has been limited.

### Background

Ponesimod (poe nes’ i mod) is an orally available sphingosine-1-phosphate (S1P) receptor modulator that acts as an immunomodulatory drug and is used to treat relapsing forms of multiple sclerosis. Ponesimod is an analogue of sphingosine and related in structure to fingolimod, the first S1P receptor modulator approved for use in multiple sclerosis. While fingolimod demonstrates non-specific S1P receptor binding (subtypes 1, 3, 4 and 5), ponesimod has a greater specificity and primarily blocks S1P receptor-1 activity. The S1P receptor modulators, once phosphorylated intracellularly, render T and B cells insensitive to signals necessary for egress from lymphoid tissue. In animal models of multiple sclerosis, ponesimod resulted in reduced recirculation of autoaggressive lymphocytes to the central nervous system. Subsequently, in several randomized controlled trials, ponesimod was shown to reduce relapse rates and improve neuro-radiologic outcomes in adult patients with relapsing multiple sclerosis. Ponesimod was approved for use in the United States in 2021 as therapy of adults with relapsing multiple sclerosis. It is available in tablets of 2 to 10 mg for dose initiation and 20 mg for maintenance therapy under the brand name Ponvory. As with other S1P receptor modulators, a period of dose escalation (14 days) is recommended for initiation of therapy with ponesimod. Ponesimod has also been shown to have beneficial effects in plaque psoriasis, but has yet to be approved for that indication. Common side effects of ponesimod (as with most S1P receptor modulators) are lymphopenia, headache, dizziness, diarrhea, cough, rhinorrhea, peripheral edema and back and abdominal pain. Rare, but potentially severe adverse events include severe viral, bacterial or fungal infections, atrial arrhythmias and bradycardia, macular edema, decrease in pulmonary function, progressive multifocal leukoencephalopathy (PML), and embryonal-fetal toxicity. Patients on long-term ponesimod should be monitored for infectious complications and for cardiac, pulmonary and ophthalmologic status.

### Hepatotoxicity

In pre-registration trials of ponesimod, serum ALT elevations were common (in up to 23% of recipients) but were typically mild and asymptomatic, returning to baseline values even with continuation of therapy or within a few months of stopping. In one prospective, carefully monitored trial, serum aminotransferase elevations above 3 times upper limit of normal (ULN) were reported in 17% of ponesimod recipients and elevations above 5 times ULN in 4.6%. In these prelicensure clinical trials, there were no cases of acute hepatitis or clinically apparent liver injury with jaundice, but elevations in liver tests led to early discontinuation in at least 2% of subjects. While ponesimod is associated with lymphopenia and long-term therapy is associated with risk for reactivation of herpes simplex and zoster infections, it has not been linked to cases of reactivation of hepatitis B although one such case has been reported with fingolimod. Thus, mild-to-moderate and transient serum enzyme elevations during therapy are common, but clinically apparent liver injury with jaundice due to ponesimod has not been reported, although the clinical experience with its use has been limited.

Likelihood score: E* (suspected but unproven cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which ponesimod might cause liver injury is not known. It is extensively metabolized by liver via multiple enzymes in the cytochrome P450 system, predominantly CYP 3A4, and drug-drug interactions with agents that induce or inhibit these enzymes are likely to occur. Serum enzyme elevations have been frequent with all of the oral S1P receptor modulators, particularly with fingolimod.

### Outcome and Management

While chronic therapy with ponesimod can be associated with mild-to-moderate serum aminotransferase elevations, it has not been linked to any cases of clinically apparent liver injury. Because of the frequency of enzyme elevations detected during therapy, the product label for ponesimod recommends obtaining baseline liver tests before initiation of treatment and monitoring for symptoms or signs of liver injury during therapy. However, no specific recommendations for monitoring liver tests during treatment have been made. Any ALT or AST elevation associated with symptoms or jaundice should lead to prompt discontinuation of ponesimod. Patients with persistent elevations above 3 times ULN should be assessed for other causes of liver injury and discontinue ponesimod if not other cause is found. There is no known cross sensitivity of the hepatic injury from ponesimod with other agents used to treat multiple sclerosis. Because of the similarity in chemical structure and mechanism of action, there may be cross-sensitivity to side effects with fingolimod, siponimod, and ozanimod.

Drug Class: Multiple Sclerosis Agents, S1P receptor modulators: Fingolimod Siponimod Ozanimod

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ponesimod – Ponvory®

DRUG CLASS

Multiple Sclerosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ponesimod&pagesize=20&page=1&audience=consumer)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ponesimod | 854107-55-4

## ANNOTATED BIBLIOGRAPHY

References updated: November 25, 2025

Abbreviations: S1P, sphingosine-1-phosphate; MRI, magnetic resonance imaging; HBV, hepatitis B virus.

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 697-8. (Expert review of hepatotoxicity published in 1999 before the availability of S1P receptor modulators).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013 does not discuss the drugs for multiple sclerosis).
Krensky AM, Azzi JR, Hafler DA. Immunotherapy for multiple sclerosis. Immunosuppressants and Tolerogens. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 649-52. (Textbook of pharmacology and therapeutics).
FDA Medical Review of NDA for Ponesimod: Pages 163-182.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/213498Orig1s000MedR.pdf (FDA website with product labels and medical review of the efficacy and safety of ponesimod mentions that serum aminotransferase elevations above 3 times ULN were not infrequent, analysis of individual instances showed no evidence for clinically apparent liver injury with jaundice).
Kappos L, Radue EW, O'Connor P, Polman C, Hohlfeld R, Calabresi P, Selmaj K, et al.; FREEDOMS Study Group. A placebo-controlled trial of oral fingolimod in relapsing multiple sclerosis. N Engl J Med 2010; 362: 387-401. PMID: (Among 1272 patients with relapsing multiple sclerosis treated with fingolimod [0.5 or 1.25 mg daily] or placebo for 24 months, 8.5-12.5% of fingolimod, but only 1.7% of placebo recipients developed ALT elevations above 3 times ULN, and ALT levels fell to normal with or without discontinuation, and serum bilirubin levels did not change). 20089952
Olsson T, Boster A, Fernández Ó, Freedman MS, Pozzilli C, Bach D, Berkani O, et al. Oral ponesimod in relapsing-remitting multiple sclerosis: a randomised phase II trial. J Neurol Neurosurg Psychiatry 2014; 85: 1198-208. (Among 464 adults with relapsing multiple sclerosis treated with ponesimod [10, 20, or 40 mg] or placebo daily for 24 weeks, cumulative numbers of active lesions on MRI between weeks 12 and 24 were lower in ponesimod- [3.4, 1.1 and 1.4] vs placebo-treated [6.2] patients and annualized relapse rates were lower with the highest dose, while adverse reactions that were more frequent with ponesimod included anxiety, dizziness, insomnia, upper respiratory tract symptoms, peripheral edema and serum ALT elevations [5.6% vs 0.8%] including ALT greater than 3 times ULN [3.8% vs none], but no ALT value was associated with symptoms or jaundice). 24659797
Vaclavkova A, Chimenti S, Arenberger P, Holló P, Sator PG, Burcklen M, Stefani M, et al. Oral ponesimod in patients with chronic plaque psoriasis: a randomised, double-blind, placebo-controlled phase 2 trial. Lancet 2014; 384(9959): 2036-45. (Among 326 patients with plaque psoriasis treated with ponesimod [20 or 40 mg] vs placebo daily for 16 weeks, clinical response rates were higher with active drug [46% and 48%] vs placebo [13%] with higher rates when treatment was continued, while adverse events of ponesimod included dyspnea, dizziness and ALT elevations [14% and 11% vs 3%] and 3 patients discontinued therapy because of ALT elevations although all were transient and none were associated with symptoms or jaundice). 25127208
Subei AM, Cohen JA. Sphingosine 1-phosphate receptor modulators in multiple sclerosis. CNS Drugs 2015; 29: 565-75. (Review of the function of the S1P receptors (subtypes 1 to 5) and the clinical implications of their differential modulation by different inhibitors). 26239599
Filippi M, Bar-Or A, Piehl F, Preziosa P, Solari A, Vukusic S, Rocca MA. Multiple sclerosis. Nat Rev Dis Primers 2018; 4: 43. (Review of the pathogenesis, clinical features, natural history, management and therapy of multiple sclerosis). 30410033
Siponimod (Mayzent)--a new drug for multiple sclerosis. Med Lett Drugs Ther 2019; 61(1571): 70-2. (Concise review of the mechanism of action, clinical efficacy, safety, and cost of siponimod in comparison to other agents used to treat multiple sclerosis; mentions that serum aminotransferase elevations can occur with siponimod therapy and that patients should be tested for liver function tests and have CYP 2C9 genotype testing before starting treatment). 31169805
Ozanimod (Zeposia) for multiple sclerosis. Med Lett Drugs Ther 2020; 62(1605): 132-134. (Concise review of the mechanism of action, clinical efficacy, toxicity, and costs of ozanimod shortly after its approval for use in relapsing multiple sclerosis in the United States mentions that ozanimod is associated with ALT and AST elevations and that therapy lowers lymphocyte counts and increases the risk of infections including herpes zoster). 32970043
Lu MC, Shih YL, Hsieh TY, Lin JC. Flare of hepatitis B virus after fingolimod treatment for relapsing and remitting multiple sclerosis. J Formos Med Assoc 2020; 119: 886-887. (Letter describing 41 year old Taiwanese woman with relapsing multiple sclerosis and inactive HBsAg carrier state who developed reactivation of hepatitis B after 35 months of treatment with fingolimod [ALT 385 U/L, HBV DNA 8 log_10_ IU/mL, bilirubin not given] who responded to tenofovir with resolution of ALT elevations and decrease of HBV DNA levels to undetectable despite continuation of fingolimod). 31679907
Drugs for multiple sclerosis. Med Lett Drugs Ther 2021; 63(1620): 42-48. (Concise review of the relative clinical efficacy, safety and costs of drugs for relapsing multiple sclerosis including parenteral agents [such as interferon-beta, glatiramer acetate, natalizumab, alemtuzumab, ocrelizumab, ofatumumab, rituximab and mitoxantrone] and the oral agents [such as the S1P receptor modulators, cladribine, fumarates, and teriflunomide] many of which are associated with serum ALT elevations and several have been reported to cause clinically apparent liver injury or reactivation of hepatitis B). 33976089
Kappos L, Fox RJ, Burcklen M, Freedman MS, Havrdová EK, Hennessy B, Hohlfeld R, et al. Ponesimod compared with teriflunomide in patients with relapsing multiple sclerosis in the active-comparator phase 3 OPTIMUM Study: a randomized clinical trial. JAMA Neurol 2021; 78: 558-567. (Among 1133 adults with relapsing multiple sclerosis treated with oral ponesimod [20 mg] or teriflunomide [14 mg] once daily for up to 2 years, the annualized relapse rate was lower with ponesimod [0.2 vs 0.3] and overall adverse event rates were similar [89% vs 88%] while ALT elevations were more frequent with ponesimod [any elevation 20% vs 9%, elevation above 3 times ULN in 17% vs 8%, and resulting in discontinuation in 9% vs 6%], yet no patient developed clinically apparent acute liver injury with jaundice). 33779698
Markham A. Ponesimod: first approval. Drugs 2021; 81: 957-962. (Review of the mechanism of action, development, clinical efficacy and safety of ponesimod shortly after its approval in the United States in 2021, mentions that serum aminotransferase elevations occurred in 23% of ponesimod recipients in one large pre-registration trial). 33939119
McGinley MP, Cohen JA. Sphingosine 1-phosphate receptor modulators in multiple sclerosis and other conditions. Lancet 2021;398:1184-94.. (Review of the function of S1P receptors and the mechanism of action of S1P receptor modulators in affecting lymphocyte tracking out of lymph nodes into the circulation and tissues; fingolimod is a nonspecific modulator affecting S1P receptors 1, 3, 4 and 5, whereas siponimod and ozanimod act predominantly on S1P receptors 1 and 5 and ponesimod against S1P receptor 1 alone, the activity against S1P receptor-1 accounting for most of the beneficial effects in multiple sclerosis and the restricted specificity perhaps accounting for the lower rate of cardiac, lung and eye adverse events driven mostly by the inhibition of the other S1P receptor subtypes). 34175020
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880.. (Extensive review of the frequency and characteristics of hepatic injury associated with different disease modifying drugs for multiple sclerosis, discusses fingolimod but not ponesimod). 34319570
Ponesimod (Ponvory) for multiple sclerosis. Med Lett Drugs Ther. 2021;63(1630):123-125.. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of ponesimod shortly after its approval for use in relapsing multiple sclerosis in the United States, mentions that adverse events include serum aminotransferase elevations in up to 23% of patients and that routine liver tests should be obtained before starting therapy). 34550110
Faissner S, Gold R. Efficacy and safety of multiple sclerosis drugs approved since 2018 and future developments. CNS Drugs. 2022;36:803-817.. (Analysis of mechanism of action, clinical efficacy, and safety of drugs for multiple sclerosis approved between 2018 and 2022, including diroximel fumarate, siponimod, ozanimod, ponesimod, ocrelizumab, and ofatumumab does not discuss liver related adverse events). 35869335
Freedman MS, Pozzilli C, Havrdova EK, Lemle A, Burcklen M, Larbalestier A, Hennessy B, et al.; Ponesimod Phase II Study Group. Long-term treatment with ponesimod in relapsing-remitting multiple sclerosis: results from randomized phase 2b core and extension studies. Neurology. 2022;99:e762-e774.. (Among 485 adults with relapsing-remitting multiple sclerosis enrolled in a core study of ponesimod [10, 20, or 40 mg vs placebo once daily for 24 weeks] and then continued in extension studies in all 3 doses, but eventually was restricted to the 20 mg dose for an average of almost 8 years, ALT elevations above 3 times ULN occurred in 10.5% of patients and a single instance accompanied by bilirubin elevations was attributed to hepatitis C). 35667837
Woodson S, Gettings EJ, Guo CY, Klineova S, Lee JM, Romero RS, Walker A, et al. Comparative effectiveness of fumarates versus sphingosine-1-phosphate receptor modulators in Black patients with multiple sclerosis. Neurol Ther. 2025;14:1627-1639.. (Analysis of health claim reports identified 1664 Black patients with multiple sclerosis who were treated a fumarate [n=2131] or an S1P receptor modulator [n=433] between 2017 and 2023, the annualized relapse rates were 0.34 vs 0.35 and 75% of patients remained relapse free; no mention of adverse event rates). 40522622
Kappos L, Burcklen M, D'Ambrosio D, Fox RJ, Freedman MS, Havrdova EK, Hennessy B, et al. Ponesimod as add-on treatment in patients with active relapsing multiple sclerosis under dimethyl fumarate (POINT): A phase 3, randomized, placebo-controlled clinical trial. Mult Scler Relat Disord. 2025;102:106616.. (Among 136 patients with active relapsing multiple sclerosis on dimethyl fumarate for at least 6 months who were treated with addition of ponesimod [20 mg] or placebo once daily for at least 60 weeks, the annualized relapse rate was similar in both groups [0.24 vs 0.19] as were adverse event rates [72% vs 78%], whereas ALT elevations above 3 times ULN arose in 7.6% vs none and above 5 times ULN in 3% vs none; but there were no instances of liver injury with jaundice). 40700861
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, one case was attributed to fingolimod and one to natalizumab, but no other agents used to treat multiple sclerosis were listed: personal communication). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Ponesimod: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ponesimod+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Ponesimod: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ponesimod)